# Betaine

## OVERVIEW

### Introduction

Betaine is a modified amino acid consisting of glycine with three methyl groups that serves as a methyl donor in several metabolic pathways and is used to treat the rare genetic causes of homocystinuria. Betaine has had only limited clinical use, but has not been linked to instances of serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Betaine (bee' ta een) is a naturally occurring modified amino acid that is used therapeutically to treat genetic homocystinuria. Homocystinuria can be caused by several inherited defects in sulfur amino acid metabolism, the most common of which are cystathionine β-synthase deficiency (CβS) and 5,10-methylenetetrahydrofolate reductase (MTHRF) deficiency. Typically, plasma levels of homocysteine and methionine are elevated while cysteine is decreased. Children with these deficiencies develop mental retardation, ocular lens dislocations, skeletal deformities and early onset atherosclerosis. Most evidence indicates that the high levels of homocysteine are the major cause of the clinical complications. Therapy of homocystinuria includes a low methionine diet, pyridoxine, a cofactor for cystathionine beta-synthase, and betaine which results in a decrease in homocysteine levels and amelioration of the clinical manifestations. Betaine is believed to act by increasing methylation reactions, one of which causes homocysteine to be metabolized to methionine. Betaine is an important nutrient that can be obtained from foods (such as beets), synthesized endogenously from choline, or provided as a supplement in patients with impaired folate status or inherited deficiencies of enzymes involved in transsulfuration pathways. The liver is rich in betaine but levels may be somewhat reduced in patients with liver disease. Betaine was approved as an orphan drug for use in homocystinuria in 1996 and is available as a powder for reconstitution in bottles of 180 grams under the brand name Cystadane. The typical dose is 3 to 10 grams twice daily. Side effects are dose related and can include gastrointestinal upset with diarrhea, bloating, cramps, dyspepsia, nausea and vomiting. Rare, but potentially severe side effects include excessive increases in serum methionine concentrations which may lead to life-threatening cerebral edema.

### Hepatotoxicity

In small, open label trials of betaine therapy for homocystinuria as well as in small controlled trials of betaine in other conditions (Alzheimer disease, nonalcoholic steatohepatitis), serum enzyme elevations and clinically apparent liver injury were not reported. Indeed, in some studies, betaine has been associated with significant declines in preexisting serum enzyme elevations in a proportion of patients with nonalcoholic fatty liver disease.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Betaine is a naturally occurring modified form of glycine that aids in the transsulfuration pathways converting homocysteine to methionine. Administration of betaine even in high doses (6 to 20 grams daily) has not been linked to hepatotoxicity.

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Betaine – Cystadane®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=betaine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Betaine | 107-43-7 | C5-H11-N-O2 | Bataine structure
Glycine | 56-40-6 | C2-H5-N-O2 | Glycine structure

## ANNOTATED BIBLIOGRAPHY

References updated: 26 September 2017

Abbreviations used: CβS, cystathionine β-synthase; MTHFR, 5,10-methylenetretrahydrofolate reductase.

Zimmerman HJ. Hepatotoxicity. The adverse effects of drugs and other chemicals upon the liver. 2nd ed. Philadelphia. Lippincott, 1999. (Textbook of drug induced liver injury published in 1999; does not discuss betaine).
Elsas L J II, Acosta PB. Homocystinuria. Nutritional support of inherited metabolic disease. In, Shils ME, Olson JA, Shihe M, Ross AC. Modern Nutrition in Health and Disease. 9th ed. Baltimore: Williams & Wilkins, 1999, pp. 1035-40. (Textbook of nutrition and therapeutics).
Smolin LA, Benevenga NJ, Berlow S. The use of betaine for the treatment of homocystinuria. J Pediatr 1981; 99: 467-72. (Two children with severe homocystinuria were treated with betaine [6.4 to 9.2 g daily] and both had prompt decline in homocysteine levels and improvement in clinical symptoms despite concurrent increases in serum methionine levels). 7264811
Wilcken DE, Wilcken B, Dudman NP, Tyrrell PA. Homocystinuria--the effects of betaine in the treatment of patients not responsive to pyridoxine. N Engl J Med 1983; 309: 448-53. (Among 10 patients with homocystinuria due to CβS deficiency who were treated with betaine [3 g twice daily] for up to 5-13 months, all had rapid decline in plasma homocysteine levels and several had improvements in clinical symptoms, while side effects were mild and no patient developed “abnormalities of hepatic, renal or bone marrow function”). 6877313
Benevenga NJ. Betaine in the treatment of homocystinuria. N Engl J Med 1984; 310: 265-6. (Letter in response to Wilcken [1983] discussing the possible role of alternate pathways of methionine catabolism in the effects of betaine on homocysteine levels in homocystinuria). 6690948
Wendel U, Bremer HJ. Betaine in the treatment of homocystinuria due to 5,10-methylene tetrahydrofolate reductase deficiency. Eur J Pediatr 1984; 142: 147-50. (In a 3 year old girl with MTHFR deficiency, betaine therapy [6-20 g daily] resulted in a decrease of homocysteine levels to trace amounts and a partial improvement in clinical symptoms “without apparent harmful effects and without signs of a disturbed liver function”). 6381059
Wilcken DE, Dudman NP, Tyrrell PA. Homocystinuria due to cystathionine beta-synthase deficiency--the effects of betaine treatment in pyridoxine-responsive patients. Metabolism 1985; 34: 1115-21. (Among 6 patients with homocystinuria with adequate control using pyridoxine alone, methionine challenge led to an increase in serum homocysteine levels, which was blunted by betaine therapy [6 g daily]; no mention of adverse events). 3934499
Gahl WA, Bernardini I, Chen S, Kurtz D, Horvath K. The effect of oral betaine on vertebral body bone density in pyridoxine-non-responsive homocystinuria. J Inherit Metab Dis 1988; 11: 291-8. (Among 5 patients with homocystinuria not responsive to pyridoxine who were treated with betaine [3 g twice daily] or placebo in a 1 year crossover design, betaine led to significant decreases in homocysteine levels and inconsistent changes in serum methionine values, but had no effect on bone mineral density, and “no side effects or intolerance of medication occurred in any patients”). 3148071
Holme E, Kjellman B, Ronge E. Betaine for treatment of homocystinuria caused by methylene tetrahydrofolate reductase deficiency. Arch Dis Child 1989; 64: 1061-4. (A 24 day old girl with homocystinuria due to MTHFR deficiency had a complete clinical remission with betaine therapy [3-6 g daily]; side effects were not discussed). 2629632
Betaine for homocystinuria. Med Lett Drugs Ther 1997 Jan 31; 39: 12. (Concise review of the mechanism of action, clinical efficacy, adverse events and costs of betaine shortly after its approval in the US as orphan drug therapy for homocystinuria; side effects included nausea, vomiting and diarrhea; no mention of ALT elevations or hepatotoxicity). 9025725
Andersson HC, Marble M, Shapira E. Long-term outcome in treated combined methylmalonic acidemia and homocystinemia. Genet Med 1999; 1: 146-50. (Among 8 patients with methylmalonic acidemia and homocystinemia treated with betaine and dietary restriction for 2-11 years, no long term adverse effects were noted). 11258350
Miglio F, Rovati LC, Santoro A, Setnikar I. Efficacy and safety of oral betaine glucuronate in non-alcoholic steatohepatitis. A double-blind, randomized, parallel-group, placebo-controlled prospective clinical study. Arzneimittelforschung 2000; 50: 722-7. (Among 191 patients with nonalcoholic steatohepatitis treated with betaine [combined with diethanolamine gluconate and nicotinamide ascorbate] or placebo for 8 weeks, serum ALT levels decreased by 11% [43 to 38 U/L] on betaine compared to slight increases on placebo [41 to 43 U/L] and other side effects were mild; no mention of worsening of ALT levels or hepatotoxicity). 10994156
Abdelmalek MF, Angulo P, Jorgensen RA, Sylvestre PB, Lindor KD. Betaine, a promising new agent for patients with nonalcoholic steatohepatitis: results of a pilot study. Am J Gastroenterol 2001; 96: 2711-7. (Among 10 patients with nonalcoholic steatohepatitis treated with betaine [10 g twice daily] for 12 months, all had a decrease or stable levels of ALT and side effects were mild but included nausea, loose stools, abdominal cramps and body odor, and “there were no adverse events noted in hematology of blood chemistry results”). 11569700
Yaghmai R, Kashani AH, Geraghty MT, Okoh J, Pomper M, Tangerman A, Wagner C, et al. Progressive cerebral edema associated with high methionine levels and betaine therapy in a patient with cystathionine beta-synthase (CBS) deficiency. Am J Med Genet 2002; 108: 57-63. (A 10 year old girl with homocystinuria due to CβS deficiency developed marked increases in serum methionine levels while on betaine therapy [6 g daily] and subsequently developed progressive cerebral edema, which resolved after stopping betaine and restricting methionine intake; there were mild and transient ALT elevations at the time of admission). 11857551
Lowering plasma homocysteine. Med Lett Drugs Ther 2003; 45: 85-6. (Concise review of methods of lowering plasma homocysteine levels as an approach to decrease atherosclerotic events, largely by use of folate and vitamin B12 supplements which together can lower levels by 7-25%, but have not been shown to decrease severe cardiovascular outcomes). 14576622
Ueland PM, Holm PI, Hustad S. Betaine: a key modulator of one-carbon metabolism and homocysteine status. Clin Chem Lab Med 2005; 43: 1069-75. (Review of the role of betaine in one carbon metabolism and its effects on homocysteine levels; “no side effects have been observed” with betaine therapy). 16197300
Yokoi K, Ito T, Ohkubo Y, Sumi S, Ueta A, Sugiyama N, Togari H. Long follow up of betaine therapy in two Japanese siblings with cystathionine beta-synthase deficiency. Pediatr Int 2008; 50: 694-5. (Two Japanese sisters with homocystinuria [CβS deficiency] were treated with betaine for more than 12 years with partial success; no mention of ALT elevations or clinically apparent liver injury). 19261122
Chaabene-Masmoudi A, Mesrati F, Zittoun J, Landrieu P. Insidious peripheral neuropathy occurring under treatment in infantile MTHFR deficiency. J Inherit Metab Dis 2009; 32 Suppl 1: S303-6. (A 15 year old girl with homocystinuria [MTHFR deficiency] on long term betaine therapy [4 g daily for more than 10 years] developed a progressive peripheral neuropathy that did not respond to further increases in betaine dose). 19697151
Abdelmalek MF, Sanderson SO, Angulo P, Soldevila-Pico C, Liu C, Peter J, Keach J, et al. Betaine for nonalcoholic fatty liver disease: results of a randomized placebo-controlled trial. Hepatology 2009; 50: 1818-26. (Among 55 patients with nonalcoholic steatohepatitis treated with betaine [10 g twice daily] or placebo for one year, there were no differences in changes in ALT, AST or homocysteine levels between the two groups, and “no clinically apparent hepatotoxicity [ALT or AST ≥3X baseline value], rise in total bilirubin value of 2X normal, or severe adverse event was reported”). 19824078
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to betaine). 25754159
Huemer M, Mulder-Bleile R, Burda P, Froese DS, Suormala T, Zeev BB, Chinnery PF, et al. Clinical pattern, mutations and in vitro residual activity in 33 patients with severe 5, 10 methylene tetrahydrofolate reductase (MTHFR) deficiency. J Inherit Metab Dis 2016; 39: 115-24. (Retrospective analysis of 33 subjects with homocystinuria and MTHFR deficiency found worse outcomes in those with lower residual enzyme activity, and betaine therapy [in 31 patients] appeared to improve biochemical and clinical features; no mention of ALT elevations or hepatotoxicity). 26025547
Day CR, Kempson SA. Betaine chemistry, roles, and potential use in liver disease. Biochim Biophys Acta 2016; 1860: 1098-106. (Review of the chemistry, distribution, metabolic functions and potential for use of betaine in chronic liver disease, focusing upon alcholic and nonalcoholic liver disease where hepatic levels of betaine may be insufficient). 26850693
Sookoian S, Puri P, Castaño GO, Scian R, Mirshahi F, Sanyal AJ, Pirola CJ. Nonalcoholic steatohepatitis is associated with a state of betaine-insufficiency. Liver Int 2017; 37: 611-9. (Serum levels of betaine were found to be lower in patients with nonalcoholic steatohepatitis than in those with fatty liver alone and lower levels were associated with worse histologic features of nonalcoholic fatty liver). 27614103

## OTHER REFERENCE LINKS

1. Recent References on Betaine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(betaine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=betaine) Trials on Betaine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Betaine)